# Trastuzumab

## OVERVIEW

### Introduction

Trastuzumab is a humanized monoclonal antibody to the human epidermal growth factor receptor 2 (HER2) which is used in combination with other antineoplastic agents in the therapy of breast and gastric cancer. Trastuzumab has been implicated in causing instances of transient serum enzyme elevations, but has only rarely been linked to instances of clinically apparent liver injury with jaundice. In contrast, the recently developed conjugates of trastuzumab with the microtubule inhibitor emtansine or the topoisomerase inhibitor deruxtecan, which are used as an antineoplastic agents for advanced resistant breast cancer, has been linked to frequent serum enzyme elevations during therapy. Trastuzumab emtansine has been linked to instances of acute clinically apparent liver injury that can be severe and even fatal and, when given chronically, to non-cirrhotic portal hypertension.

### Background

Trastuzumab (tras tooz’ ue mab) is a humanized monoclonal antibody to HER2 which is a human epidermal growth factor receptor that is overexpressed in 20% to 25% of breast cancers and a smaller proportion of other cancers such as gastric, lung, ovarian and pancreatic. The interaction of epidermal growth factor (EGF) with HER2 results in rapid cell growth and proliferation via intracellular pathways. Binding of trastuzumab to HER2 blocks this cell signaling pathway and causes growth arrest. Trastuzumab was shown to decrease recurrences and prolong survival in patients with breast cancer that were HER2 positive. Trastuzumab was approved for use in the United States in 1998 and current indications include breast and gastric cancers that express HER2. Trastuzumab is available in single use vials of 150 mg lyophilized powder generically under the brand name Herceptin. The typical dose is 2 to 8 mg/kg intravenously weekly or every three weeks, the dose and duration of therapy varying with different indications. Common side effects include fatigue, nausea and vomiting, diarrhea, infusion reactions, rash, headache, fever, cough, dyspnea, neutropenia, infections, thrombocytopenia, and anemia. Rare, but serious side effects include severe infusion reactions (usually with the initial dose), cardiomyopathy (especially when combined with an anthracycline), pneumonitis, tumor lysis syndrome and fetal toxicity. Trastuzumab should be prescribed and administered only by health care workers with expertise and experience in cancer chemotherapy and management of its adverse events.

Trastuzumab emtansine (em tan’ seen) and transtuzumab deruxtecan (de rux” tee can) are conjugates of trastuzumab with toxic molecules, which are released after binding and uptake by HER2 expressing cells and are used in the therapy of metastatic breast, gastric, or lung cancers that express HER2. The two conjugates have separate toxicities and their likelihood of causing hepatotoxicity varies, perhaps due to the different toxin conjugates rather than the monoclonal antibody. These monoclonal antibody conjugates are discussed separately in different chapters in LiverTox.

### Hepatotoxicity

In large registration trials of trastuzumab for advanced or metastatic breast and other cancers, rates of serum enzyme elevations and instances of clinically apparent liver injury are rarely mentioned. In one large study, ALT elevations arose in 3% of patients treated but there were no instances of clinically apparent liver disease. The package insert for trastuzumab does not provide information of the rate of serum ALT or AST elevations or report cases of liver injury. Since its approval and widescale use, there have been at least 4 published case reports of serum ALT elevations occurring after 1 to 8 cycles of trastuzumab therapy. One case was symptomatic but none were accompanied by jaundice or hyperbilirubinemia. Immune allergic features and autoantibodies were not present. The abnormalities improved on stopping therapy and in one case recurred in a similar pattern on re-exposure. Abnormalities of liver enzymes during trastuzumab therapy are often attributed to progressive disease or hepatic effects of other medications being given with the monoclonal antibody. Thus, trastuzumab can probably cause clinically significant liver injury but it is uncommon, mild and usually self-limited in course, resolving with discontinuation.

Likelihood score: C (probable rare cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of the serum enzyme elevations during trastuzumab therapy is not known, but may be due to the direct effect of inhibiting human epidermal growth factor signaling in liver. While the liver injury may be dose related and may be a mild direct toxicity of the infusions, other possibilities are that it is caused by the antineoplastic agents that are used with trastuzumab such as doxorubicin, cyclophosphamide, paclitaxel, docetaxel, carboplatin, or 5-fluorouracil.

### Outcome and Management

The liver injury attributed to trastuzumab has invariably been self-limited and not associated with symptoms or jaundice. There is no information on possible cross sensitivity to the injury among different monoclonal antibodies or therapies directed at epidermal growth factor receptors. In some instances, trastuzumab has been tolerated at lower doses after recovery with minimal ALT elevations.

Drug Class: Antineoplastic Agents, Monoclonal Antibodies

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Trastuzumab – Herceptin®

DRUG CLASS

Antineoplastic Agents

Trastuzumab Conjugates: Trastuzumab Emtansine, Trastuzumab Deruxtecan

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?label=all&query=Trastuzumab) (Trastuzumab)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Trastuzumab | 180288-69-1 (https://pubchem.ncbi.nlm.nih.gov/compound/Trastuzumab) | Monoclonal Antibody | Not Available

## ANNOTATED BIBLIOGRAPHY

References updated: 30 January 2024

Abbreviations: CT, computerized tomography; HER-2, human epidermal growth factor receptor 2; MR, magnetic resonance; NRH, nodular regenerative hyperplasia; TNF, tumor necrosis factor.

Zimmerman HJ. Hepatotoxic effects of oncotherapeutic and immunosuppressive agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 673-708. (Expert review of hepatotoxicity published in 1999; well before the availability of most monoclonal antibody therapies).
Reuben A. Hepatotoxicity of immunosuppressive drugs. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2011, pp. 569-91. (Review of hepatotoxicity of immunosuppressive drugs mentions that "the biological immunosuppressants are largely free from hepatotoxicity, with the exception of the TNF alpha antagonists").
Wellstein A, Giaccone G, Atkins MB, Sausville EA. Pathway-targeted therapies: monoclonal antibodies, protein kinase inhibitors, and various small molecules. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1203-36. (Textbook of pharmacology and therapeutics).
Trastuzumab and capecitabine for metastatic breast cancer. Med Lett Drugs Ther 1998; 40 (1039): 106-8. (Concise review of the mechanism of action, efficacy, safety and cost of trastuzumab to be used alone or with paclitaxel; adverse events include infusion reactions, diarrhea and cardiac toxicity [when combined with an anthracycline]; no mention of ALT elevations or hepatotoxicity). 9814369
Cobleigh MA, Vogel CL, Tripathy D, Robert NJ, Scholl S, Fehrenbacher L, Wolter JM, et al. Multinational study of the efficacy and safety of humanized anti-HER2 monoclonal antibody in women who have HER2-overexpressing metastatic breast cancer that has progressed after chemotherapy for metastatic disease. J Clin Oncol 1999; 17: 2639-48. (Among 222 women with HER2 overexpressing metastatic breast cancer who were treated with trastuzumab once weekly, one developed an anaphylactoid reaction and 5 [3%] had ALT elevations above 5 times the ULN, but most liver enzyme abnormalities were associated with progressive disease, and there were no deaths from liver failure). 10561337
Smith IE. Efficacy and safety of Herceptin in women with metastatic breast cancer: results from pivotal clinical studies. Anticancer Drugs 2001; 12 Suppl 4: S3-10. (Analysis of safety data from 930 patients in clinical trials and over 30,000 from postmarketing surveillance indicates that trastuzumab is usually well tolerated, the most common side effect being infusion reactions, mainly with the first dose, serious reactions occurring in 0.3% of patients; trastuzumab may also have cardiac toxicity). 11989525
Vogel CL, Cobleigh MA, Tripathy D, Gutheil JC, Harris LN, Fehrenbacher L, Slamon DJ, et al. Efficacy and safety of trastuzumab as a single agent in first-line treatment of HER2-overexpressing metastatic breast cancer. J Clin Oncol 2002; 20: 719-26. (Among 114 women with metastatic breast cancer treated with two doses of trastuzumab "severe laboratory abnormalities were uncommon"; no mention of ALT elevations or hepatotoxicity). 11821453
Jones RL, Smith IE. Efficacy and safety of trastuzumab. Expert Opin Drug Saf 2004; 3: 317-27. (Review of efficacy and safety of trastuzumab mentions that it is generally well tolerated, with specific discussion of infusion reactions, cardiac and pulmonary toxicity; no mention of ALT elevations or hepatotoxicity). 15268649
Capitain O, Lortholary A, Abadie-Lacourtoisie S. [Cytolytic hepatitis and esomeprazole during chemotherapy]. Presse Med 2005; 34: 1235-6. French. (41 year old woman with breast cancer developed fatigue on the fifth day of the second course of trastuzumab and paclitaxel and one day after taking one dose of esomeprazole [bilirubin normal, ALT 14 times ULN, Alk P 1.5 times ULN], resolving within 8 days and not recurring with subsequent courses of the chemotherapy). 16230965
Romond EH, Perez EA, Bryant J, Suman VJ, Geyer CE Jr, Davidson NE, Tan-Chiu E, et al. Trastuzumab plus adjuvant chemotherapy for operable HER2-positive breast cancer. N Engl J Med 2005; 353: 1673-84. (Among 3351 women with breast cancer enrolled in two controlled trials of standard chemotherapy with or without trastuzumab, with an average follow up of 2.0 years, survival and disease free survival were superior with trastuzumab; no mention of hepatotoxicity or ALT elevations). 16236738
Piccart-Gebhart MJ, Procter M, Leyland-Jones B, Goldhirsch A, Untch M, Smith I, Gianni L, et al.; Herceptin Adjuvant (HERA) Trial Study Team. Trastuzumab after adjuvant chemotherapy in HER2-positive breast cancer. N Engl J Med 2005; 353: 1659-72. (Among 5081 women with breast cancer randomized to receive trastuzumab [for 1 or 2 years] or observation, survival and disease free survival were greater in trastuzumab treated patients; toxicity included rare cases of congestive heart failure and death, but no mention of hepatotoxicity or ALT elevations). 16236737
Smith I, Procter M, Gelber RD, Guillaume S, Feyereislova A, Dowsett M, Goldhirsch A, et al.; HERA study team. 2-year follow-up of trastuzumab after adjuvant chemotherapy in HER2-positive breast cancer: a randomised controlled trial. Lancet 2007; 369 (9555): 29-36. (Further follow up of trial of observation vs 1 or 2 years of trastuzumab in 5102 women with breast cancer receiving conventional chemotherapy found more serious and fatal adverse events in the trastuzumab treated patients, but none were attributed to liver injury). 17208639
Muñoz A, Carrera S, Ferreiro J, de Lobera AR, Mañé JM, López-Vivanco G. Reversible liver toxicity with adjuvant trastuzumab for localized breast cancer. Ann Oncol 2007; 18: 2045-6. (31 year old woman with breast cancer developed marked ALT elevations [1403 U/L] after first infusion of trastuzumab [8 mg/kg], which resolved within 4 weeks and did not recur with subsequent lower dose regimens, although minor ALT continued to occur thereafter). 18083694
Srinivasan S, Parsa V, Liu CY, Fontana JA. Trastuzumab-induced hepatotoxicity. Ann Pharmacother 2008; 42: 1497-501. (54 year old woman with breast cancer on paclitaxel and trastuzumab developed progressive increases in ALT, starting with first dose and resulting in discontinuation after 8th cycle, falling to normal thereafter). 18780811
Burris HA 3rd, Rugo HS, Vukelja SJ, Vogel CL, Borson RA, Limentani S, Tan-Chiu E, et al. Phase II study of the antibody drug conjugate trastuzumab-DM1 for the treatment of human epidermal growth factor receptor 2 (HER2)-positive breast cancer after prior HER2-directed therapy. J Clin Oncol 2011; 29: 398-405. (Among 112 patients with advanced breast cancer despite previous therapy who were treated with trastuzumab emtansine for an average of 4 months, common side effects were fatigue, nausea, and headache; rates of ALT elevations were not provided, but one patient stopped therapy early because of "thrombocytopenia and hepatotoxicity"). 21172893
Verma S, Miles D, Gianni L, Krop IE, Welslau M, Baselga J, Pegram M, et al.; EMILIA Study Group. Trastuzumab emtansine for HER2-positive advanced breast cancer. N Engl J Med 2012; 367: 1783-91. (Among 991 women with HER2 expressing breast cancer who had failed previous therapy who received either trastuzumab emtansine or lapatinib with capecitabine, overall survival was improved with the antibody conjugate, but ALT levels were elevated in 17%, AST in 22%, and platelets decreased in 28% of patients; 3 patients stopped therapy early because of aminotransferase elevations, but no patient had both bilirubin and marked ALT elevations and there were no liver related deaths). 23020162
Krop IE, LoRusso P, Miller KD, Modi S, Yardley D, Rodriguez G, Guardino E, et al. A phase II study of trastuzumab emtansine in patients with human epidermal growth factor receptor 2-positive metastatic breast cancer who were previously treated with trastuzumab, lapatinib, an anthracycline, a taxane, and capecitabine. J Clin Oncol 2012; 30: 3234-41. (Among 110 patients with advanced, resistant breast cancer treated with trastuzumab emtansine for an average of 17 months, ALT elevations occurred in 14% and one patient died from "abnormal hepatic function"). 22649126
Vucicevic D, Carey EJ, Karlin NJ. Trastuzumab-induced hepatotoxicity: a case report. Breast Care (Basel) 2013; 8: 146-8. (60 year old woman was found to have serum enzyme elevations without symptoms 41 days after finishing 6 months [8 cycles] of trastuzumab and while receiving trastuzumab exemestane [bilirubin 1.0 mg/dL, ALT 91 rising to 523 U/L, Alk P 100 rising to 231 U/L, INR 0.94], resolving incompletely 4 months later). 24419371
Ado-trastuzumab emtansine (Kadcyla) for HER2-positive metastatic breast cancer. Med Lett Drugs Ther 2013; 55 (1425): 75-6. (Concise summary of mechanism of action, efficacy, safety and costs of ado-trastuzumab emtansine, a conjugate of trastuzumab with a microtubule inhibitor mentions that increased aminotransferase levels occurred in more than 25% of patients and serious, sometimes fatal, liver toxicity has been reported). 24662957
Force J, Saxena R, Schneider BP, Storniolo AM, Sledge GW Jr, Chalasani N, Vuppalanchi R. Nodular regenerative hyperplasia after treatment with trastuzumab emtansine. J Clin Oncol 2016; 34 (3): e9-12. (Two women, ages 66 and 50 years, with metastatic breast cancer presented with evidence of portal hypertension [ascites, varices, low platelet counts] 16 months after starting cyclic therapy with ado-trastuzumab emtansine [bilirubin normal, ALT 48 and ~120 U/L, Alk P 400 U/L and not given], biopsy showing nodular regenerative hyperplasia and both patients improving when the agent was stopped). 24778392
Miller KD, Diéras V, Harbeck N, Andre F, Mahtani RL, Gianni L, Albain KS, et al. Phase IIa trial of trastuzumab emtansine with pertuzumab for patients with human epidermal growth factor receptor 2-positive, locally advanced, or metastatic breast cancer. J Clin Oncol 2014; 32: 1437-44. (Among 64 women with HER2 positive metastatic breast cancer [HER2 positive] treated with the combination of pertuzumab and trastuzumab emtansine [every 3 weeks], common side effects were fatigue [61%], nausea [50%] and diarrhea [39%] and "hepatic dysfunction" in 38% with ALT levels above 5 times ULN in 9%). 24733796
Ishizuna K, Ninomiya J, Ogawa T, Tsuji E. Hepatotoxicity induced by trastuzumab used for breast cancer adjuvant therapy: a case report. J Med Case Rep 2014; 8: 417. (60 year old Japanese woman with breast cancer developed liver test abnormalities after a second cycle of trastuzumab [bilirubin normal, ALT 246 U/L, Alk P 553 U/L], which recurred one year later after readministration of a single infusion [bilirubin normal, ALT 102 U/L, Alk P 377 U/L], resolving within 2 months of stopping). 25491149
Spano JP, Beuzeboc P, Coeffic D, Arnould L, Lortholary A, Andre F, Ferrero JM. Long term HER2+ metastatic breast cancer survivors treated by trastuzumab: Results from the French cohort study LHORA. Breast 2015; 24: 376-83. (Among 160 women with breast cancer treated with trastuzumab [for a median of 5.3 years], long term adverse events included cardiac failure and cardiomyopathy; no mention of ALT elevations or hepatotoxicity). 25913287
Ghabril M, Vuppalanchi R. Drug-induced nodular regenerative hyperplasia. Semin Liver Dis 2014; 34: 240-5. (Review of the clinical presentation, etiology, course and management of nodular regenerative hyperplasia which is often due to medications including trastuzumab emtansine). 24879987
Diéras V, Harbeck N, Budd GT, Greenson JK, Guardino AE, Samant M, Chernyukhin N, Smitt MC, Krop IE. Trastuzumab emtansine in human epidermal growth factor receptor 2-positive metastatic breast cancer: an integrated safety analysis. J Clin Oncol 2014; 32: 2750-7. (Among 884 patients with HER2 positive breast cancer treated with trastuzumab emtansine in 6 controlled trials, common adverse events were fatigue [46%], nausea [43%], thrombocytopenia [32%], headache [29%], constipation [27%] and ALT elevations [16%], typically during the first few months, rising to above 5 times ULN in 3.1%, resulting in drug discontinuation in 0.5% and death in 2 patients). 25024070
Mandaliya H, Baghi P, Prawira A, George MK. A rare case of paclitaxel and/or trastuzumab induced acute hepatic necrosis. Case Rep Oncol Med 2015; 2015: 825603. (62 year old woman with HER2 positive breast cancer developed acute respiratory failure within 12 hours of first dose of paclitaxel and trastuzumab, liver test results “were inconclusive” and she died 36 hours later: “surprisingly, autopsy showed acute hepatic/liver necrosis”). 26605100
Bishop AJ, Ensor J, Moulder SL, Shaitelman SF, Edson MA, Whitman GJ, Bishnoi S, et al. Prognosis for patients with metastatic breast cancer who achieve a no-evidence-of-disease status after systemic or local therapy. Cancer 2015; 121: 4324-32. (Among 570 patients with metastatic breast cancer seen between 2003 and 2005 at a single referral center, overall 5 year survival was 24%, but was higher in those who achieved “no evidence of disease” status [78% vs 13%] and those who received trastuzumab, no mention of adverse events or hepatotoxicity). 26348887
Giuliani J, Bonetti A. Acute liver failure caused by metastatic breast cancer: can we expect some results from chemotherapy? Dig Dis Sci 2015; 60: 2541-3. (35 year old woman with HER2 positive breast cancer developed evidence of metastatic replacement of the liver [bilirubin 5.0 mg/dL, ALT 236 U/L, GGT 449 U/L] and improvement with combination chemotherapy including trastuzumab, liver tests returning to normal but then died with progressive disease 9 months later, indicating that this symptom is not as grim as previously reported using more modern chemotherapy regimens). 26088368
Sharp A, Johnston SR. Dose-reduced trastuzumab emtansine: active and safe in acute hepatic dysfunction. Case Rep Oncol 2015; 8: 113-21. (59 year old woman with HER2 positive breast cancer, refractory after multiple chemotherapy regimens, developed jaundice associated with a 7 cm liver mass [bilirubin ~8.2 mg/dL, ALT ~1000 U/L, Alk P ~650 U/L], which responded to therapy with trastuzumab emtansine with resolution of jaundice, improvement in liver enzymes, and shrinkage of the mass). 25873876
Gelmon KA, Boyle FM, Kaufman B, Huntsman DG, Manikhas A, Di Leo A, Martin M, et al. Lapatinib or trastuzumab plus taxane therapy for human epidermal growth factor receptor 2-positive advanced breast cancer: final results of NCIC CTG MA.31. J Clin Oncol 2015; 33: 1574-83. (Among 652 patients with HER2 positive advanced breast cancer treated with lapatinib or trastuzumab combined with a taxane, progression free survival was better with trastuzumab, while symptoms of rash, diarrhea and febrile neutropenia were more common with lapatinib, decrease in left ventricular function arose in 2.3% of trastuzumab vs 0% of lapatinib recipients, and “hepatic dysfunction” occurred in <1% of both groups). 25779558
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, only four cases were attributed to a monoclonal antibody [3 to infliximab and 1 to adalimumab]; no cases were attributed to trastuzumab). 25754159
Yan H, Endo Y, Shen Y, Rotstein D, Dokmanovic M, Mohan N, Mukhopadhyay P, et al. Ado-trastuzumab emtansine targets hepatocytes via human epidermal growth factor receptor 2 to induce hepatotoxicity. Mol Cancer Ther 2016; 15: 480-90. (In cultured human and mouse hepatocytes and in mouse models, trastuzumab emtansine can cause hepatocellular injury after binding to cell surface HER2 receptors and uptake into hepatocytes). 26712117
Bunchorntavakul C, Reddy KR. Drug hepatotoxicity: newer agents. Clin Liver Dis 2017; 21: 115-34. (Review of literature on hepatotoxicity of newly approved agents mentions that trastuzumab can cause ALT elevations in 7-12% of patients and rarely acute hepatitis but has not been linked to reactivation of HBV, while trastuzumab emtansine causes ALT elevations in 17-22% of patients and has been linked to cases of hepatitis, acute liver failure, portal hypertension and nodular regenerative hyperplasia [NRH], but not to reactivation of HBV). 27842767
Liu Y, Li ZY, Li X, Wang JN, Huang QA, Huang Y. Liver toxicity of chemotherapy and targeted therapy for breast cancer patients with hepatitis virus infection. Breast 2017; 35: 191-5. (Among 835 patients with breast cancer receiving targeted therapy, rates of ALT elevations were slightly higher in the 52 with HBsAg [35%] and the 21 with anti-HCV [43%] than controls [28%] as were rates of chemotherapy disruption for liver test abnormalities [9.6% and 9.5% vs 5%], but no patient developed viral reactivation, although the proportion of those with HBsAg who were receiving antiviral prophylaxis was not provided). 28800545
Liu Y, Li ZY, Wang JN, Li X, Huang QA, Huang Y. Effects of hepatitis C virus infection on the safety of chemotherapy for breast cancer patients. Breast Cancer Res Treat 2017; 164: 379-83. (Among 835 patients with breast cancer receiving target therapy, rates of “hepatitis” were slightly higher in the 21 with anti-HCV in serum [23%] than in controls [14%] as were rates of chemotherapy disruption for liver test abnormalities [9.5% vs 5%], but no patient develop viral reactivation as define by a 1 log increase in HCV RNA levels). 28447238
Hidalgo-Blanco A, Aguirresarobe-Gil de San Vicente M, Aresti S, de Miguel E, Cabriada-Nuno JL. Pseudocirrhosis in metastatic breast cancer. Gastroenterol Hepatol 2018; 41: 111-3. (39 year old woman with HER2 positive breast cancer received a 1 year course of trastuzumab at the end of which she had normal ALT levels and CT appearance of the liver, but 18 months later she presented with abnormalities of both suggestive of pseudocirrhosis). 28187872
Lepelley M, Allouchery M, Long J, Boucherle D, Ranchoup Y, Le Marc'Hadour F, Villier C, Sturm N. Nodular regenerative hyperplasia induced by trastuzumab emtansine: role of emtansine? Ann Hepatol 2018; 17: 1067-71. (48 year old woman with HER2-negative breast cancer in 2008 had recurrence in 2012 that was HER2-positive and after 12 months of trastuzumab emtansine therapy presented with mild ALT and AST elevations and MRI showing splenomegaly and dystrophic liver a biopsy of which showed NRH, liver abnormalities improving but cancer progressing when chemotherapy was stopped). 30600283
Talima S, Kassem H, Kassem N. Chemotherapy and targeted therapy for breast cancer patients with hepatitis C virus infection. Breast Cancer 2019; 26: 154-63. (Two of 58 Egyptian women with advanced breast cancer and chronic hepatitis C developed viral reactivation during targeted chemotherapy, one on lapatinib and one trastuzumab). 30191397
Fujii Y, Doi M, Tsukiyama N, Hattori Y, Ohya K, Shiroma N, Morio K, et al. Sinusoidal obstruction syndrome post-treatment with trastuzumab emtansine (T-DM1) in advanced breast cancer. Int Cancer Conf J 2019; 9: 18-23. (Two women with metastatic HER2 positive breast cancer developed noncirrhotic portal hypertension 2.5 and 4.5 years of trastuzumab emtansine therapy, in both of whom liver biopsy showed sinusoidal obstruction syndrome and disordered hepatic plates). 31950012
Milam P, Berger M, Ramaswamy B, Reinbolt R, Wesolowski R, Kaffenberger BH. Spider telangiectases and palmar erythema as harbingers of structural liver changes in three breast cancer patients on ado-trastuzumab emtansine. J Clin Aesthet Dermatol 2019; 12: 23-6. (Three women [ages 53, 60 and 63 years] with advanced breast cancer developed cutaneous stigmata of cirrhosis after 17 to 34 cycles of trastuzumab emtansine with spider angiomas and palmar erythema, minimal ALT and AST elevations, decreased platelet counts [43,000-123,000/µL], and usually with splenomegaly and nodular liver on CT or MR imaging). 31531159
Duret-Aupy N, Lagarce L, Blouet A, Kettani S, Conte C, Bourneau-Martin D, Drablier G, et al. Liver sinusoidal obstruction syndrome associated with trastuzumab emtansine treatment for breast cancer. Therapie 2019; 74: 675-7. (87 year old woman on trastuzumab emtansine for two years developed variceal hemorrhage, ascites and edema, with normal ALT, and CT showing no evidence of cirrhosis, but liver biopsy showing sinusoidal obstruction syndrome). 31023619
Nodehi RS, Kalantari B, Raafat J, Ansarinejad N, Moazed V, Mortazavizadeh SMR, Hosseinzadeh M, et al. A randomized, double-blind, phase III, non-inferiority clinical trial comparing the efficacy and safety of TA4415V (a proposed Trastuzumab biosimilar) and Herceptin (Trastuzumab reference product) in HER2-positive early-stage breast Cancer patients. BMC Pharmacol Toxicol. 2022;23:57. (Among 92 patients with early stage HER2 positive breast cancer treated with conventional chemotherapy followed by adjuvant trastuzumab or a biological equivalent, the objective response rate was 83% and 89% and adverse event rates were similar; no mention of hepatotoxicity or ALT elevations). 35902898
Sun C, Yang X, Tang L, Chen J. A pharmacovigilance study on drug-induced liver injury associated with antibody-drug conjugates (ADCs) based on the food and drug administration adverse event reporting system. Expert Opin Drug Saf. 2023:1-12. (Analysis of the FDA reporting system [FAERS] for cases of drug induced liver injury submitted between 2004 and 2022, found 17,784 reports, 504 [3%] attributed to antibody-drug conjugates, 202 from the US, the implicated agents being gemtuzumab ozogamicin [n=98], brentuximab vedotin [n=37], trastuzumab emtansine [n=25], enfortumab vedotin [n=16], inotuzumab ozogamicin [n=15], transtuzumab deruxtecan [n=8], and polatuzumab vedotin [3]). 37898875

## OTHER REFERENCE LINKS

Recent References on Trastuzumab: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Trastuzumab+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

Trials on Trastuzumab: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Trastuzumab)